# Inclisiran

## OVERVIEW

### Introduction

Inclisiran is a synthetic small interfering RNA (siRNA) molecule directed against PCSK-9 that is used to treat hypercholesterolemia. Inclisiran has not been linked to ALT elevations during therapy or to instances of clinically apparent liver injury with symptoms or jaundice.

### Background

Inclisiran (in clis’ er an) is a synthetic, double-stranded, small interfering RNA (siRNA) directed against the mRNA of PCSK9 (proprotein convertase subtilisin/kexin type 9), a small polypeptide produced in the liver than binds to and causes degradation of the low density lipoprotein (LDL) cholesterol receptor. The binding of PCSK9 to the receptor leads to its internalization and lysosomal digestion, resulting in less uptake of LDL cholesterol from the serum and rise in cholesterol levels. Inhibition of this protein prevents the breakdown of the LDL cholesterol receptor, resulting in an increase in LDL cholesterol by the liver and a marked decrease in serum LDL cholesterol. The siRNA molecule is covalently linked to three N-acetylgalactosamine residues, which facilitate its uptake by hepatocytes. Once taken up by cells, the siRNA is cleaved into smaller fragments and separated into single strands that bind and silence the mRNA of PCSK9. In animal models, inclisiran reduced PCSK9 mRNA levels in liver and PCSK9 protein in serum, which was accompanied by an increase in hepatocyte LDL cholesterol receptors and decrease in serum LDL cholesterol. In placebo controlled trials of inclisiran in patients with hypercholesterolemia, single subcutaneous injections resulted in dose related reductions in serum cholesterol levels that persisted for several weeks. With 3 to 6 monthly injections of higher doses, serum LDL cholesterol levels fell by 50%. Inclisiran was approved for use in the United States in 2021 for patients with heterozygous familial hypercholesterolemia or patients with a history of cardiovascular disease with inadequate lowering of serum LDL cholesterol by statins due to resistance or intolerance of statin side effects. Inclisiran is available in solution in single dose prefilled syringes of 284 mg in 1.5 mL under the brand name Leqvio. The recommended dose regimen is 284 mg initially and again 3 months later, followed by every 6 months. Administration should be by a health care provider. Inclisiran is generally well tolerated, but side effects can include injection site reactions, fatigue, arthralgias, diarrhea and musculoskeletal pains. In preregistration studies, 5% to 13% of inclisiran treated patients developed anti-drug antibodies, but their presence was not associated with decreased efficacy or safety.

### Hepatotoxicity

In multiple pivotal trials, inclisiran therapy was well tolerated and serum ALT elevations arose in less than 1% of patients that were invariably transient, mild-to-moderate in severity, and without accompanying symptoms or jaundice. In controlled trials, rates of ALT and AST elevations during inclisiran therapy were similar to those with placebo or comparator agents. Since its approval and more widescale use, there have been no published reports of liver injury attributed to inclisiran therapy. Thus, inclisiran is an unlikely cause of clinically apparent liver injury, although it still has had limited clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of hepatic injury from inclisiran or other siRNA therapeutics is not known. One possibility is that suppression of intracellular PCSK9 levels might cause or predispose to liver injury. Inclisiran, like other siRNA therapeutic agents, is metabolized intracellularly by nucleases and is not a substrate of cytochrome P450 enzymes or hepatic transporters.

### Outcome and Management

Inclisiran has not been linked to ALT elevations or to clinically apparent liver injury and regular monitoring of routine liver tests is not recommended.

Drug Class: Genetic Disorder Agents, Antilipemic Agents

Other Therapeutic siRNA-based Agents: Eteplirsen, Givosiran, Golodirsen, Patisiran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Inclisiran – Leqvio®

DRUG CLASS

Genetic Disorder Agents, Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=6fc0afca-4513-4c35-b594-6544aee29a44)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Inclisiran | 1639324-58-5 (https://pubchem.ncbi.nlm.nih.gov/substance/381127835) | C529-H707-F12-N176-O316-P43-S6 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 06 January 2023

Abbreviations: mRNA, messenger RNA; PCSK9, proprotein convertase subtilisin/kexin type 9; siRNA, small interfering RNA.

FDA. Inclisiran. Clinical Review. 2021. Available at:
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/214012Orig1s000MedR.pdf (The FDA clinical review of inclisiran for efficacy and safety; reported ALT elevations above 5 times ULN arose in 6 of 2990 [0.2%] inclisiran treated patients, all of which were transient and asymptomatic and none were associated with jaundice).
Setten RL, Rossi JJ, Han SP. (2019). The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics, which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]).
Fitzgerald K, Frank-Kamenetsky M, Shulga-Morskaya S, Liebow A, Bettencourt BR, Sutherland JE, Hutabarat RM, et al. (2014). Effect of an RNA interference drug on the synthesis of proprotein convertase subtilisin/kexin type 9 (PCSK9) and the concentration of serum LDL cholesterol in healthy volunteers: a randomised, single-blind, placebo-controlled, phase 1 trial. Lancet. (In a phase 1, dose-finding and safety study of single injections of inclisiran or placebo in 32 patients not receiving medications for hypercholesterolemia, inclisiran led to a rapid 50% decline in PCSK9 levels and marked decline in LDL cholesterol levels at the highest doses that was sustained for several weeks, and there were no drug related serious adverse events).
Fitzgerald K, White S, Borodovsky A, Bettencourt BR, Strahs A, Clausen V, Wijngaard P, et al. (2017). A highly durable RNAi therapeutic inhibitor of PCSK9. N Engl J Med. (In a phase 1 dose findings of single or multiple doses of inclisiran, maximum reduction in LDL cholesterol was achieved with 300 mg doses, which were sustained for 6 months while adverse events were mild-to-moderate in severity and self-limited in course, one patient on inclisiran developing ALT levels above 2 times ULN improved on stopping atorvastatin and had recurrence on restarting it).
Ray KK, Landmesser U, Leiter LA, Kallend D, Dufour R, Karakas M, Hall T, et al. (2017). Inclisiran in patients at high cardiovascular risk with elevated LDL cholesterol. N Engl J Med. (In a phase 2 trial of multiple ascending doses of one or two doses of inclisiran vs placebo, the 2 dose regimen of 300 mg of inclisiran yielded the greatest reduction in LDL cholesterol, and adverse event rates were similar between two groups with ALT levels above 3 times ULN in 2 of 370 [0.5%] on inclisiran vs none of 127 on placebo).
Page MM, Watts GF. (2018). PCSK9 in context: A contemporary review of an important biological target for the prevention and treatment of atherosclerotic cardiovascular disease. Diabetes Obes Metab. (Review of the role of PCSK9 in cholesterol metabolism and the efficacy and safety of monoclonal antibody inhibitors of circulating levels [evolocumab and alirocumab ] and siRNA inhibitors of its synthesis [inclisiran].
Ray KK, Wright RS, Kallend D, Koenig W, Leiter LA, Raal FJ, Bisch JA, et al., ORION-10 and ORION-11 Investigators. (2020). Two phase 3 trials of inclisiran in patients with elevated LDL cholesterol. N Engl J Med. (Among 3178 patients with atherosclerotic cardiovascular disease [or at high risk for it] and high LDL cholesterol levels despite statin therapy in 2 placebo controlled trials of inclisiran [300 mg at 0, 90, 270and 450 days], LDL cholesterol levels decreased by 50-52% with inclisiran and adverse event rates were similar to placebo except for injection site reactions [4.7% vs 0.5%]; ALT levels rising above 3 times ULN in 0.4% of both groups).
Raal FJ, Kallend D, Ray KK, Turner T, Koenig W, Wright RS, Wijngaard PLJ, et al. (2020). ORION-9 Investigators. Inclisiran for the treatment of heterozygous familial hypercholesterolemia. N Engl J Med. (Among 482 adults with heterozygous familial hypercholesterolemia treated with inclisiran [300 mg] or placebo on days 0, 90, 270 and 450, LDL cholesterol levels decreased by 40% on inclisiran but increased by 8% on placebo, while adverse event rates were similar in the two groups except for injection site reactions [17% vs 1.7%], ALT levels above 3 times ULN occurring in 1.2% [3 of 241 inclisiran-] vs 0.4% [1 of 240 placebo recipients]).
(2022). Inclisiran (Leqvio) for LDL-cholesterol lowering. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of inclisiran shortly after its approval for use in the United States, mentions side effects of injection site reactions [8%], arthralgia, urinary tract infections, diarrhea, bronchitis, extremity pain and dyspnea; no mention of ALT elevations or hepatotoxicity.
(2022). Lipid-lowering drugs. Med Lett Drugs Ther. (Concise summary of efficacy, safety and costs of lipid-lowering drugs approved for use in the US mentions that inclisiran lowers LDL cholesterol levels by about 50% when added to maximally tolerated statin therapy, but includes no mention of serious adverse events, ALT elevations or hepatotoxicity).
Ranasinghe P, Addison ML, Dear JW, Webb DJ. (2022). Small interfering RNA: Discovery, pharmacology and clinical development–An introductory review. Br J Pharmacol. (Review of the history of development, mechanism of action, methods of delivery, clinical efficacy and safety of RNA silencing drugs including lumasiran, givosiran, inclisiran, patisiran and vutrisiran, discusses adverse events from inclisiran of injection site reactions, but does not mention hepatotoxicity or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Inclisiran: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Inclisiran/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))
2 Trials on Inclisiran: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=Inclisiran)